# Pentazocine

## OVERVIEW

### Introduction

Pentazocine is a synthetic opioid with both agonist and antagonist activity against opiate receptors which was previously used in oral and parenteral forms as an analgesic for moderate-to-severe pain. Currently, it is only available in tablet form in combination with either acetaminophen or naloxone. Pentazocine has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury.

### Background

Pentazocine (pen taz’ oh seen) is a synthetic opioid that has both partial agonist and antagonist activity and is similar to butorphanol. Pentazocine has weak antagonist or partial agonist activity to the µ type opiate receptors, with full agonist activity at the ĸ opioid receptor. These actions lead to typical analgesic effects of the opioids at low doses, but with a dysphoric effect at higher doses, which is believed to limit its abuse potential and puts a ceiling on its analgesic effect. Pentazocine was first approved for use in the United States in 1967 for treatment of mild-to-moderate pain but is now rarely used. Oral formulations of pentazocine are available only in fixed combinations (50 mg) with acetaminophen (Telacen and generics) or naloxone (Talwin Nx and generics). The addition of acetaminophen or naloxone is believed to prevent or discourage injection and abuse of pentazocine (the naloxone being an opiate antagonist that is active only with parenteral administration). Side effects of pentazocine include sedation, respiratory depression, confusion, euphoria, agitation, itching, sweating, abdominal bloating, nausea, vomiting and constipation, adverse effects which are typical of the opioids. In addition, pentazocine can cause confusion, disorientation and hallucinations. Pentazocine is a controlled substance and is classified as a Schedule IV drug, indicating that it has medical usefulness and a mild potential for physical and psychological dependency and abuse. Internationally and in some states, pentazocine is classified as a Schedule III drug, indicating a greater potential for dependency and abuse.

### Hepatotoxicity

Therapy with pentazocine has not been linked to serum enzyme elevations or to idiosyncratic acute, clinically apparent liver injury.

Likelihood score: E (unlikely cause of drug-induced liver injury).

References on the safety and potential hepatotoxicity of pentazocine are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pentazocine – Generic, Talwin®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pentazocine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pentazocine | 359-83-1 | C19-H27-N-O

## OTHER REFERENCE LINKS

1 Recent References on Pentazocine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pentazocine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Pentazocine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pentazocine)